# Mogamulizumab

## OVERVIEW

### Introduction

Mogamulizumab is a humanized monoclonal antibody to the T cell CC chemokine receptor 4 which is used to treat peripheral and cutaneous T-cell lymphomas. Mogamulizumab is associated with a low rate of serum enzyme elevations during treatment and has been linked to several instances of reactivation of hepatitis B.

### Background

Mogamulizumab (moe gam" ue liz' ue mab) is a recombinant humanized monoclonal antibody to the CC chemokine receptor type 4, which is found on helper T cells and is highly expressed on malignant T cells as occurs in cutaneous and peripheral T cell lymphomas. Mogamulizumab is defucosylated and the removal of these sugar molecules makes the antibody more avid in inducing antibody dependent cellular cytotoxicity. Clinical trials of mogamulizumab in refractory or relapsing cases of cutaneous T cell lymphoma (Sézary syndrome and mycosis fungoides) have shown that it decreases malignant T cells and induces objective responses in a proportion of patients. Mogamulizumab was approved for use in the United States in 2018 for therapy of patients with relapsed or refractory mycosis fungoides or Sézary syndrome. Mogamulizumab is available in solution in single dose vials of 20 mg/5 mL (4 mg/mL) under the brand name Poteligeo. Mogamulizumab is administered as an intravenous infusion in a dose of 1 mg/kg on days 1, 8, 15 and 22 of the first 28-day cycle and on days 1 and 15 of subsequent chemotherapy cycles. Side effects are generally mild-to-moderate in severity but can be severe and include rash, infusion reactions, autoimmune complications and, in patients with hematopoietic cell transplants, severe acute graft-versus-host disease. Rare, but potentially severe adverse events include reactivation of infections including hepatitis B.

### Hepatotoxicity

In prelicensure clinical trials of mogamulizumab in Sézary syndrome, mycosis fungoides and adult T-cell lymphomas, serum aminotransferase elevations occurred in 18% to 25% of recipients, but the abnormalities were generally mild and self-limited and often attributable to other underlying conditions. Elevations of ALT above 5 times the ULN occurred in only 1% of subjects and no patient developed both serum aminotransferase and bilirubin elevations or clinically apparent liver injury. Mogamulizumab has also been associated with induction of autoimmune conditions and at least one case of autoimmune hepatitis that arose after successful mogamulizumab therapy and that required long-term corticosteroid therapy.

In Japan where mogamulizumab was approved for adult T cell lymphoma in 2015, several instances of reactivation of hepatitis B have been reported, at least one of which was fatal and most of which occurred in patients with antibody to HBV without detectable HBsAg or HBV DNA before therapy ("reverse seroconversion"). The treated patients had received multiple other chemotherapeutic agents and the specific role of mogamulizumab in inducing an increase in HBV replication was not always clear. Since approval in the United States, there have been no published reports of clinically apparent acute liver injury or reactivation of hepatitis B attributed to mogamulizumab, but it has had limited general use.

Likelihood score: C (probable cause of clinically apparent liver injury largely due to reactivation of hepatitis B and induction of autoimmune conditions).

### Mechanism of Injury

Mogamulizumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. Recombinant proteins are often metabolized in the cells on which they act but are also metabolized in the liver, largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Mogamulizumab therapy may affect normal T cell function, particularly regulatory T cells that may express CC chemokine receptor 4 (CXCR4) on cell surface membranes. These effects may explain the induction of autoimmune conditions as well as reactivation of hepatitis B by mogamulizumab.

### Outcome and Management

Serum enzyme elevations during mogamulizumab therapy are usually transient and mild, but induction of autoimmune hepatitis even months after successful therapy has been described. Autoimmune hepatitis may require corticosteroid therapy. Reactivation of hepatitis B can result in severe hepatitis and even acute hepatic failure. Patients who are to receive potent immunosuppressive therapy such as with ibrutinib, rituximab or mogamulizumab should be screened for hepatitis B markers, including HBsAg and anti-HBc before starting therapy, and those who are positive given prophylaxis against reactivation using oral antiviral agents with activity against HBV such as tenofovir and entecavir or monitored carefully for changes in HBV DNA levels during therapy. If HBV DNA levels increase significantly (by 10-fold or greater; at least one log increase in HBV DNA), initiation of antiviral therapy is appropriate. Therapy should be continued for at least six months after immunosuppressive therapy has been completed.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mogamulizumab – Poteligeo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Mogamulizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mogamulizumab | 1159266-37-1 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of monoclonal immunosuppressive agents written before the availability of mogamulizumab; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Danan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that “hepatitis” was reported in 8% of 319 patients treated with mogamulizumab, but that there were no cases of hepatitis with jaundice and rates of ALT elevations were similar in comparator arms [19% vs 21% receiving vorinostat]).
Ogura M, Ishida T, Hatake K, Taniwaki M, Ando K, Tobinai K, Fujimoto K, et al. Multicenter phase II study of mogamulizumab (KW-0761), a defucosylated anti-cc chemokine receptor 4 antibody, in patients with relapsed peripheral T-cell lymphoma and cutaneous T-cell lymphoma. J Clin Oncol 2014; 32: 1157-63. (Among 37 patients with relapsed peripheral or cutaneous T-cell lymphoma treated with mogamulizumab, 35% had an objective response and side effects included lymphopenia [81%], skin rash [51%], fever [30%], infusion reactions [24%] and ALT elevations [22%] which were above 5 times ULN in only one subject [3%]). 24616310
Nakano N, Kusumoto S, Tanaka Y, Ishida T, Takeuchi S, Takatsuka Y, Akinaga S, et al. Reactivation of hepatitis B virus in a patient with adult T-cell leukemia-lymphoma receiving the anti-CC chemokine receptor 4 antibody mogamulizumab. Hepatol Res 2014; 44: 354-7. (65 year old woman with relapsed adult T-cell lymphoma [with anti-HBc without HBsAg or HBV DNA] developed reactivation of HBV 6 months after starting intermittent mogamulizumab therapy becoming HBsAg and HBV DNA positive [bilirubin not given, ALT 205 U/L, HBV DNA 7.8 million IU/mL], responding to entecavir therapy). 23601025
Ifuku H, Kusumoto S, Tanaka Y, Totani H, Ishida T, Okada M, Murakami S, et al. Fatal reactivation of hepatitis B virus infection in a patient with adult T-cell leukemia-lymphoma receiving the anti-CC chemokine receptor 4 antibody mogamulizumab. Hepatol Res 2015; 45: 1363-7. (72 year old man with adult T-cell lymphoma developed fatal reactivation of HBV [peak bilirubin ~31 mg/dL, ALT 3,080 U/L] shortly after starting mogamulizumab, having become HBsAg and HBV DNA positive before starting monoclonal antibody therapy after 8 previous cycles of cytotoxic chemotherapy). 25753008
Totani H, Kusumoto S, Ishida T, Masuda A, Yoshida T, Ito A, Ri M, et al. Reactivation of hepatitis B virus (HBV) infection in adult T-cell leukemia-lymphoma patients with resolved HBV infection following systemic chemotherapy. Int J Hematol 2015; 101: 398-404. (Among 24 patients with adult T cell lymphomas with antibody to HBV without HBsAg who received systemic chemotherapy, 3 [13%] developed HBV reactivation during prospective monitoring of HBV DNA levels, but none developed hepatitis having been promptly treated with entecavir; 2 of the 3 received mogamulizumab, the 3rd had undergone hematopoietic cell transplantation). 25633779
Duvic M, Pinter-Brown LC, Foss FM, Sokol L, Jorgensen JL, Challagundla P, Dwyer KM, et al. Phase 1/2 study of mogamulizumab, a defucosylated anti-CCR4 antibody, in previously treated patients with cutaneous T-cell lymphoma. Blood 2015; 125: 1883-9. (Among 41 patients with cutaneous T-cell lymphoma treated with mogamulizumab, the objective response rate was 37% and adverse events included nausea [31%], fever [24%], infusion reactions [21%] and drug eruptions [17%]; no mention of ALT elevations or hepatotoxicity). 25605368
Sugio T, Kato K, Aoki T, Ohta T, Saito N, Yoshida S, Kawano I, et al. Mogamulizumab treatment prior to allogeneic hematopoietic stem cell transplantation induces severe acute graft-versus-host disease. Biol Blood Marrow Transplant 2016; 22: 1608-14. (Among 25 patients with acute T cell lymphoma treated with mogamulizumab before hematopoietic cell transplantation, graft-vs-host disease was more frequent and more severe than in patients who had not received mogamulizumab). 27220263
Phipps C, Chen Y, Tan D. Lymphoproliferative disease and hepatitis B reactivation: challenges in the era of rapidly evolving targeted therapy. Clin Lymphoma Myeloma Leuk 2016; 16: 5-11. (Review of reactivation of hepatitis B caused by targeted therapies of lymphoproliferative diseases; mentions two cases of HBV reactivation with reverse seroconversion during mogamulizumab therapy of adult T cell lymphomas). 26705677
Kim YH, Bagot M, Pinter-Brown L, Rook AH, Porcu P, Horwitz SM, Whittaker S, et al.; MAVORIC Investigators. Mogamulizumab versus vorinostat in previously treated cutaneous T-cell lymphoma (MAVORIC): an international, open-label, randomised, controlled phase 3 trial. Lancet Oncol 2018; 19: 1192-204. (Among 370 patients with refractory cutaneous T cell lymphoma treated with mogamulizumab or vorinostat, median progression-free survival was greater with the monoclonal antibody [7.7 vs 3.1 months], while adverse event rates were less except for infusion site reactions [24% vs 1%] and skin eruptions [24% vs 1%] while AST elevations occurred in 4% vs 7%, and there were no severe hepatic adverse reactions). 30100375
Sato T, Coler-Reilly ALG, Yagishita N, Araya N, Inoue E, Furuta R, Watanabe T, et al. Mogamulizumab (anti-CCR4) in HTLV-1-associated myelopathy. N Engl J Med 2018; 378: 529-38. (Among 21 patients with HTLV-1 associated myelopathy and adult T cell lymphoma treated with mogamulizumab, reduction in spasticity occurred in 79% of patients and infusions were well tolerated; 1 patient developed transient AST elevations above 5 times ULN which resolved rapidly upon stopping therapy). 29414279
Miyagawa F, Yamamoto S, Miyao M, Nishikawa M, Ogawa K, Asada H. Predisposition to multi-drug hypersensitivity after administration of mogamulizumab. Eur J Dermatol 2018; 28: 526-8. (59 year old woman with refractory adult T-cell leukemia-lymphoma developed a severe cutaneous reaction a few days after a third infusion of mogamulizumab, which resolved on stopping but recurred on two occasions when started on other medications without mogamulizumab). 29952299
Bonnet P, Battistella M, Roelens M, Ram-Wolff C, Herms F, Frumholtz L, Bouaziz JD, et al. Association of autoimmunity and long-term complete remission in patients with Sézary syndrome treated with mogamulizumab. Br J Dermatol 2019; 180: 419-20. (Two of 21 patients with refractory cutaneous T cell lymphomas treated with mogamulizumab developed autoimmune conditions (one with vitiligo and autoimmune hepatitis and one with hemolytic anemia) after successful treatment and long term complete responses with mogamulizumab). 30328116

## OTHER REFERENCE LINKS

1. Recent References on Mogamulizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mogamulizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Mogamulizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mogamulizumab)